# Nedosiran

## OVERVIEW

### Introduction

Nedosiran is a synthetic small interfering RNA molecule directed against the mRNA of lactic dehydrogenase A that is used to treat the rare genetic disease primary hyperoxaluria type 1. Nedosiran has not been linked to serum aminotransferase elevations during therapy or to instances of clinically apparent liver injury with symptoms or jaundice.

### Background

Nedosiran (ned” oh sir' an) is a synthetic, double-stranded, small interfering RNA (siRNA) directed against the mRNA of lactic dehydrogenase A (LDH-A), an enzyme made in the liver, the inhibition of which decreases the production of oxalate, a stable molecule that is excreted in the kidneys. Nedosiran was developed to treat primary hyperoxaluria type 1, a rare autosomal recessive disease marked by excessive production of oxalate due to a deficiency in the enzyme alanine-glyoxylate aminotransferase, which converts glyoxylate (the precursor of oxalate) to glycine. As a result, children with primary hyperoxaluria type 1 produce excessive oxalate in the liver which overwhelms the capacity of the kidney for excretion and results in formation of insoluble calcium oxalate crystals leading to nephrocalcinosis, recurrent kidney stones and progressive renal damage. With renal dysfunction, oxalate also accumulates in other organs causing damage to bone, skin, vascular endothelium, heart, eye and brain. The clinical manifestations of primary hyperoxaluria type 1 are variable but progressive renal failure is prominent and can lead to death in childhood or young adulthood. To facilitate its hepatic uptake, nedosiran is covalently linked to three N-acetylgalactosamine residues which bind to and are taken up by the hepatocyte-specific asialoglycoprotein receptor. Once taken up by liver cells, the siRNA is cleaved into smaller fragments and separated into single strands that bind and silence the mRNA of LDH-A. In animal models, nedosiran reduced LDH-A mRNA levels in liver and oxalate accumulation in liver and kidneys. In placebo controlled trials of nedosiran in patients with primary hyperoxaluria type 1, subcutaneous injections resulted in dose related reductions in serum and urinary oxalate levels. With 3 to 6 monthly injections, oxalate levels fell by more than 50%. Nedosiran was approved for use in the United States in 2023 for children (9 years of age or older) and adults with primary hyperoxaluria type 1, the second siRNA therapy approved for treatment of primary hyperoxaluria (after lumasiran in 2020). Nedosiran is available in solution in single dose vials of 80 mg in 0.5 mL, and in prefilled syringes of 128 mg (0.8 mL) or 160 mg (1.0 mL) under the brand name Rivfloza. The recommended dose regimen varies by age and body weight. For adults and adolescents weighing at least 50 kg, the dose is 160 mg subcutaneously once monthly. Nedosiran, like lumasiran, is indicated only for hyperoxaluria type 1, there being 3 forms of the genetic condition, types 2 and 3 being less responsive to these siRNA therapies. Unlike lumasiran, nedosiran can be self-administered. Nedosiran is generally well tolerated, the most common adverse events are injection site reactions.

### Hepatotoxicity

In the small registration trial of nedosiran in 35 children and adults with primary hyperoxaluria type 1, therapy was well tolerated and side effects attributed to the drug were few, transient and generally mild. Rates of ALT and AST elevations during therapy were similar with nedosiran vs placebo and usually less than twice above the upper limit of the normal range. Since its approval, there have been no published reports of liver injury attributed to nedosiran therapy. Nedosiran has had limited general clinical use, but it is an unlikely cause of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of hepatic injury from nedosiran or other siRNA therapeutics is not known. Nedosiran, like other siRNA therapeutic agents, is metabolized intracellularly by nucleases and is not a substrate of cytochrome P450 enzymes or hepatic transporters.

### Outcome and Management

Nedosiran has not been linked to liver test abnormalities or to clinically apparent liver injury and regular monitoring of routine liver tests is not recommended.

Drug Class: Genetic Disorder Agents, siRNA and Antisense Agents

Other Therapeutic siRNA-based Agent for Hyperoxaluria: Lumasiran

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nedosiran – Rivfloza®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nedosiran)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Nedosiran | 2266591-83-5 | C662-H808-F19-N231-O413-P57-S6-Na57 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 05 March 2025

Abbreviations: mRNA, messenger RNA; siRNA, small interfering RNA.

FDA. Nedosiran. Integrated Review. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/215842Orig1s000TOC.cfm (The FDA clinical review of nedosiran for efficacy and safety reported from a controlled trial in 35 patients with primary hyperoxaluria, among whom there were no deaths or drug related serious adverse events, injection site erythema was the most frequent adverse event arising in 22% [vs none on placebo], minor ALT elevations arose in similar number of nedosiran-treated as placebo recipients and in longer term studies, ALT elevations above 3 times ULN occurred in one treated patient, which were transient and resolved rapidly despite continuation of therapy and were considered unrelated to nedosiran).
Setten RL, Rossi JJ, Han SP. The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov 2019; 18: 421-46. (Extensive review of gene silencing using RNA interference pathways and the potential of siRNA therapeutics which have promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]). 30846871
Forbes TA, Brown BD, Lai C. Therapeutic RNA interference: a novel approach to the treatment of primary hyperoxaluria. Br J Clin Pharmacol. 2022;88:2525-2538. (Review of the RNA interference pathway that leads to targeted degradation or translational inhibition of mRNA and its potential as therapy of primary hyperoxaluria). 34022071
Ranasinghe P, Addison ML, Dear JW, Webb DJ. Small interfering RNA: Discovery, pharmacology and clinical development–An introductory review. Br J Pharmacol. 2023; 180: 2697-2720. (Review of the history of development, mechanism of action, methods of delivery, clinical efficacy and safety of RNA silencing drugs including lumasiran, givosiran, inclisiran, patisiran and vutrisiran; discusses adverse events from lumasiran of injection site reactions, but does not mention hepatotoxicity or ALT elevations). 36250252
Baum MA, Langman C, Cochat P, Lieske JC, Moochhala SH, Hamamoto S, Satoh H, et al.; PHYOX2 study investigators. PHYOX2: a pivotal randomized study of nedosiran in primary hyperoxaluria type 1 or 2. Kidney Int. 2023;103:207-217. (Among 35 patients with primary hyperoxaluria type 1 or 2 treated with nedosiran or placebo injected subcutaneously once monthly for 6 months, oxalate excretion decreased with nedosiran, and levels were within the normal range in 50% vs none during the last 3 months of therapy, which was “generally safe and well tolerated” and “no clinically important changes in laboratory or other clinical parameters …were observed”). 36007597
Goldfarb DS, Lieske JC, Groothoff J, Schalk G, Russell K, Yu S, Vrhnjak B. Nedosiran in primary hyperoxaluria subtype 3: results from a phase I, single-dose study (PHYOX4). Urolithiasis. 2023;51:80. (Among 6 patients with primary hyperoxaluria type 3 given a single injection or nedosiran or placebo, urinary oxalate levels decreased by 24% with nedosiran while increasing with placebo and side effects were mild and there were no “safety concerns”). 37118061
Syed YY. Nedosiran: first approval. Drugs. 2023;83:1729-1733. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of nedosiran shortly after its approval for use in the US, mentions that side effects are mild, mostly due to injection site reactions and rarely lead to drug discontinuation; no mention of ALT elevations or hepatotoxicity). 38060091
Groothoff J, Sellier-Leclerc AL, Deesker L, Bacchetta J, Schalk G, Tönshoff B, Lipkin Get al. Nedosiran safety and efficacy in PH1: interim analysis of PHYOX3. Kidney Int Rep. 2024;9:1387-1396. (Among 13 patients with primary hyperoxaluria type 1 who participated in a controlled trial of nedosiran who were then enrolled in a long term, open label study of the drug’s efficacy and safety, urinary oxalate excretion remained at normal [75%] or near normal levels and side effects were generally mild, and “no clinically relevant trends were noted for laboratory assessments”). 38707801
Milliner DS, Harris PC, Sas DJ, Cogal AG, Lieske JC. Primary hyperoxaluria type 1. In: Adam MP, Feldman J, Mirzaa GM, Pagon RA, Wallace SE, Amemiya A, editors. GeneReviews® [Internet]. Seattle (WA): University of Washington, Seattle; 1993–2025. (Extended summary of the clinical characteristics, etiology, diagnosis, long-term outcomes, and management of primary hyperoxaluria type 1).
Wanders RJA, Groothoff JW, Deesker LJ, Salido E, Garrelfs SF. Human glyoxylate metabolism revisited: New insights pointing to multi-organ involvement with implications for siRNA-based therapies in primary hyperoxaluria. J Inherit Metab Dis. 2025;48:e12817. (Review of glyoxylate metabolism and the molecular basis for the 3 forms of primary hyperoxaluria, which have important implications for the development of siRNA therapies). 39582099
Sas DJ, Bakkaloglu SA, Belostotsky V, Hayes W, Ariceta G, Zhou J, Rawson V. Nedosiran in pediatric patients with PH1 and relatively preserved kidney function, a phase 2 study (PHYOX8). Pediatr Nephrol. 2025 Jan 28. Epub ahead of print. (Among 15 children [ages 2 to 11] with primary hyperoxaluria type 1 and preserved renal function who were treated with nedosiran monthly for 6 months, urinary oxalate excretion decreased by 64% and while 73% of children had at least one adverse event, none resulted in drug discontinuation, and therapy “did not lead to any significant changes in laboratory or other clinical measurements”). 39875734

## OTHER REFERENCE LINKS

1. Recent References on Nedosiran: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nedosiran/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))

2. Trials on Nedosiran: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=Nedosiran)